# Vancomycin

## OVERVIEW

### Information

Vancomycin is a broad spectrum antibiotic that has activity against methicillin-resistant strains of Staphylococcus aureus and is generally reserved for serious drug resistant gram-positive infections. Vancomycin therapy has been linked many to instances of hypersensitivity with fever, rash and eosinophilia that can be associated with hepatic injury and DRESS syndrome, but has only rarely been associated with severe or life-threatening liver injury.

### Background

Vancomycin (van" koe mye' sin) is a glycopeptide antibiotic produced by Streptococcus orientalis with primary activity against gram positive bacteria. Vancomycin has a large, complex and unusual structure and is believed to act by inhibition of bacterial cell wall synthesis via binding to the cell wall precursor molecules. Vancomycin is active against, and its major use is in therapy of, infections due to methicillin-resistant Staphylococcus aureus (MRSA), including antibiotic-induced pseudomembranous colitis, staphylococcal enterocolitis, bacterial endocarditis, and sepsis. Vancomycin is not well absorbed orally and for systemic infections it is given intravenously. It is frequently used in combination with other antibiotics and started before bacterial sensitivity results are available. For localized or nonsystemic infections, other routes of administration are used, including oral, rectal, topical, inhalational, intrathecal, intraperitoneal, and intraventricular. The recommended parenteral dosage in adults is 500 mg iv every 6 hours or 1000 mg every 12 hours, with modification to achieve a therapeutic range as needed. The recommended oral dosage in the treatment of antibiotic induced pseudomembranous enterocolitis is 125 to 500 mg every 6 hours for 7 to 10 days. Vancomycin is available generically and under several commercial names including Vancoled, Vancor, Lyphocin, and Vancocin in 125 and 250 mg pulvules and as power for injection or oral administration. Vancomycin was first approved for use in the United States in 1958 and it continues to be widely used, particularly with the recent rise in incidence of serious MRSA infections. Vancomycin is largely well tolerated; common side effects include diarrhea, nausea, nephrotoxicity and neutropenia. Uncommon but potentially severe adverse reactions include infusion reactions, flushing reactions, anaphylaxis, nephrotoxicity, ototoxicity, hypersensitivity reactions including Stevens-Johnson syndrome, and drug reactions with rash, eosinophilia and systemic symptoms (DRESS syndrome).

### Hepatotoxicity

Intravenous vancomycin is associated with minor, transient and asymptomatic elevations in serum aminotransferase levels in 1% to 5% of patients, but similar or minimally lower rates of abnormalities are usually reported with comparative agents. In rare instances, the serum enzyme elevations are more marked and may be associated with mild symptoms, although usually without jaundice. In recent years, vancomycin has been linked to hypersensitivity reactions, including Stevens-Johnson syndrome, toxic epidermal necrolysis and, most commonly, the distinctive syndrome of drug reaction with eosinophilia and systemic symptoms (DRESS). These forms of hypersensitivity generally occur only after 2 to 4 weeks of prolonged continuous intravenous (iv) vancomycin therapy. Fever and severe skin rash generally dominate the clinical presentation, but systemic symptoms can include renal, respiratory or heart failure, adenopathy, neutropenia, thrombocytopenia, facial edema, and liver injury. Cases of DRESS syndrome associated with vancomycin are often accompanied by serum enzyme elevations (Case 1), but marked elevations, symptoms of liver injury, and jaundice are uncommon. The usual systemic features of vancomycin induced DRESS syndrome are renal rather than liver injury but features of hypersensitivity may be more prominent than organ-specific injury. Nevertheless, in rare instances the liver injury can be severe (Case 2) and result in hepatic failure and death. Patients who receive intravenous vancomycin often have multiple comorbidities including sepsis and receive multiple antibiotics which make the attribution of the hypersensitivity reactions and liver injury with vancomycin difficult. Other more well-known causes of DRESS syndrome include allopurinol, sulfonamides, and the aromatic anticonvulsants. These other causes of DRESS syndrome are more likely to be associated with clinically apparent and even fatal liver injury. DRESS syndrome associated with vancomycin is almost invariably associated with the allele HLA-B*32:01, which can be used in diagnosis and potentially used to screen for this reaction if results can be obtained promptly (before or during the first week of therapy).

Vancomycin is also associated with several forms of acute infusion reactions, most notably anaphylaxis and the vancomycin flushing reaction, previously known as “red man syndrome”. Vancomycin flushing reactions occur typically during the first 15 to 20 minutes of an initial infusion of vancomycin, most commonly when given rapidly and in relative high doses (1000 mg given over less than 60 minutes). The reaction is characterized by flushing, erythema, and itching usually of the face, neck and upper torso, sometimes accompanied by chest and back pain and variable degrees of hypotension. Rarely, flushing reactions have been associated with oral vancomycin therapy, particularly in elderly patients with active colitis and renal dysfunction. The cause of the symptoms is probably the acute degranulation of mast cells by the direct effect of vancomycin or S. Aureus toxins. The mediator of the reaction is histamine and other active amines or components in mast cell granules. Plasma histamine levels are usually elevated in persons with vancomycin flushing reactions, but the correlation of changes in plasma histamine levels and severity of symptoms is poor. Nevertheless, the symptoms of the vancomycin flushing reaction can be prevented or ameliorated by pretreatment with antihistamines. Perhaps a better approach is the use of slower infusion rates and lower doses of vancomycin. Liver injury is not a feature of vancomycin flushing reactions but can arise secondarily in cases with prolonged or severe hypotension.

Likelihood score: A (well established cause of clinically apparent liver injury usually in association with prolonged intravenous therapy and presenting with DRESS syndrome).

### Mechanism of Injury

Vancomycin is rapidly excreted in the urine without significant hepatic metabolism, which perhaps explains the lack of significant direct hepatotoxicity. Hypersensitivity probably accounts for the instances of hepatitis associated with DRESS syndrome and Stevens-Johnson syndrome due to intravenous vancomycin. Case series have recently shown a close association of vancomycin induced DRESS syndrome with the HLA allele A*32:01, which was detected in 83% of vancomycin induced DRESS syndrome cases but only 6% of population controls. Interestingly, this allele was not associated with cases of Stevens-Johnson syndrome related to vancomycin. The association of ALT elevations and the vancomycin flushing reaction with oral vancomycin is surprising in view of its lack of oral absorption, but the presence of active colitis may allow for some systemic exposure.

### Outcome and Management

In published cases, the hepatic injury has usually been self-limited, but rare instances of acute liver failure in the context of hypersensitivity reactions have been linked to vancomycin therapy. Vancomycin should be discontinued promptly in patients who develop immunoallergic features. Corticosteroids are often used to treat the systemic hypersensitivity and relapse may occur when they are discontinued early. In general, spontaneous recovery is usually slow despite early discontinuation of vancomycin, while corticosteroids generally result in rapid resolution. There is no evidence for cross sensitivity to hypersensitivity reactions to vancomycin with other antibiotics, except in some instances for teicoplanin, a vancomycin-like antibiotic available in some countries, but not the United States.

Drug Class: Antiinfective Agents

Other Drugs in the Subclass, Glycopeptide Antibiotics: Dalbavancin, Oritavancin, Telavancin

## CASE REPORT

### Case 1. DRESS Syndrome without jaundice attributed to intravenous vancomycin therapy.(1)

A 64 year old man with diabetes, severe obesity, hyperlipidemia, asthma and depression developed DRESS syndrome have receiving intravenous vancomycin for an infected hematoma, a complication of bilateral hernia repair. The patient had a long history of obesity and at one point was found to have serum ALT elevations which were attributed to nonalcoholic fatty liver. After bilateral hernia repair operation he developed a local hematoma that became infected and was treated with intravenous vancomycin (1.5 to 2 mg daily) and piperacillin/tazobactam which was discontinued after 5 days and switched to oral ciprofloxacin and metronidazole. After 10 days of vancomycin therapy, he developed fever followed by rash, and vancomycin was discontinued. The rash worsened and he developed evidence of both renal and hepatic injury leading to his admission. A skin biopsy and the presence of eosinophilia supported the diagnosis of DRESS syndrome and he was started on prednisone. Serum ALT levels rose to 1200 U/L with an alkaline phosphatase of 256 U/L and an INR of 1.8, while bilirubin levels increased slightly to a peak of 1.9 mg/dL. Serum creatinine peaked at 1.9 mg/dL. These values had been normal before the onset of DRESS (Table). His rash as well as both renal and hepatic tests began to improve and he was discharged and followed monthly in clinic. At 6 and 9 months after onset, he was asymptomatic, no longer taking prednisone and both liver and kidney tests were all within in normal range.

#### Key Points

Medication: | Vancomycin (1.5 mg daily) iv for 14 days
Pattern: | Hepatocellular (R=6.2 rising to 11.3]
Severity: | Mild (enzyme elevations without jaundice)
Latency: | 2 weeks
Recovery: | 2 months
Other medications: | Piperacillin/tazobactam, ciprofloxacin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 30 | 67 | 0.5
0 | Pre | 27 | 78 | 0.4 | INR 1.1
15 days | 0 | Rash and fever: Vancomycin stopped
3 weeks | 6 days | 301 | 78 | 0.6 | INR 1.5
| 7 days | 580 | 94 | 0.5 | Prednisone started
| 8 days | 791 | 111 | 0.5 | Creatinine 1.9 mg/dL
| 9 days | 1168 | 242 | 1.2 | INR 1.8
| 10 days | 1200 | 238 | 1.7 | INR 1.8
| 11 days | 1000 | 256 | 1.9 | INR 1.5
4 weeks | 2 weeks | 619 | 258 | 1.3 | Discharged
5 weeks | 3 weeks | 129 | 134 | 0.6
| 5 weeks | 50 | 77 | 0.4
2 months | 7 weeks | 47 | 70 | 0.3
| 3 months | 47 | 78 | 0.4 | Prednisone stopped: INR 1.0
| 4 months | 38 | 76 | 0.3
| 5 months | 36 | 64 | 0.5
10 months | 9 months | 54 | 66 | 0.5 | Creatinine 0.8 mg/dL
Normal Values | | <75 | <120 | <1.2

#### Comment

This man with diabetes, severe obesity and suspected nonalcoholic fatty liver disease developed DRESS syndrome 2 weeks after starting intravenous vancomycin for a postoperative infection. Despite stopping vancomycin fairly promptly and initiation of corticosteroid therapy a week later, liver tests worsened for another ten days before they began to improve. In follow up, he was able to stop the corticosteroid therapy and liver tests remained normal. As is typical of DRESS syndrome induced by vancomycin, renal dysfunction was also present and also resolved with prednisone therapy and time. He had also received piperacillin with tazobactam, an antibiotic that is also capable of causing DRESS syndrome. Interestingly, HLA testing done on a stored serum sample showed the absence of HLA-A*32:01 (typical of vancomycin) and the presence of A*02:01 (typical of penicillin-induced liver injury) suggesting that the injury may have been due to piperacillin; this was Case 3 in the publication by Asif et al [2024].

### Case 2. DRESS Syndrome with jaundice due to vancomycin therapy.(1)

A 60 year old man with acute bacterial endocarditis due to Staphylococcus aureus was initially treated with intravenous vancomycin and nafcillin. Vancomycin was discontinued after 3 days when sensitivity results showed that the S. aureus was methicillin-sensitive. Two weeks later he developed rash and renal dysfunction that was attributed to nafcillin, which was discontinued and vancomycin restarted. Three weeks later he developed a worsening rash that spread to his entire body accompanied by fever and facial edema. He had recently been started on hydralazine because of hypertension not adequately controlled by metoprolol. Laboratory testing showed marked eosinophilia (16%) and abnormal liver tests with ALT 2018 U/L, AST 1232 U/L, Alk P 343 U/L and bilirubin 1.3 mg/dL. Renal function had worsened and serum creatinine was 6.4 mg/dL. Vancomycin and hydralazine were stopped and he was followed as an outpatient. A few days later his rash was worse and he was admitted for evaluation and therapy. A skin biopsy suggested a drug reaction. Tests for hepatitis A, B and C, Epstein Barr virus and cytomegalovirus were negative as were autoantibodies. Serum immunoglobulins were normal. Hydralazine was stopped and high dose corticosteroids were started. Thereafter, he improved rapidly and prednisone dose was slowly lowered. When seen 3, 5 and 6 months after onset, his liver tests were normal, but he remained on low doses of prednisone.

#### Key Points

Medication: | Vancomycin (1.5 gm iv daily for 3 weeks)
Pattern: | Hepatocellular (R=28.2)
Severity: | Severe (INR >1.5)
Latency: | 3 weeks after restarting
Recovery: | 3 months on prednisone
Other medications: | Nafcillin, hydralazine (2 weeks), metoprolol

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Albumin (g/dL) | INR | Comments
0 | Pre | Started on intravenous nafcillin and vancomycin for bacterial endocarditis
3 days | | Vancomycin discontinued: S. aureus methicillin-sensitive
9 days | | 17 | 32 | 0.3 | 3.5
18 days | | 19 | 60 | 0.6 | 2.0 | | Vancomycin restarted
21 days | | 37 | 107 | 0.4 | 3.4 | 1.1
40 days | 0 | 2018 | 260 | 1.3 | 3.8 | | Vancomycin stopped
| 1 days | 1645 | 339 | 1.8 | | | Creatinine 6.4 mg/dL
| 7 days | 457 | 343 | 3.0
| 8 days | 361 | 293 | 2.3 | 2.8 | 1.6 | Prednisone started
| 9 days | 361 | 327 | 2.0 | 2.8 | 1.5
| 10 days | 384 | 292 | 1.9 | 2.7 | 1.5
| 14 days | 328 | 255 | 1.7 | 3.0 | 1.3
| 22 days | 85 | 176 | 0.9 | 3.5 | 1.1
| 31 days | 49 | 118 | 0.7
| 41 days | 38 | 114 | 0.5
3 months | 2 months | 21 | 98 | 0.5
| 3 months | 21 | 84 | 0.5
| 5 months | 17 | 32 | 0.3 | | 1.1
7 months | 6 months | 20 | 75 | 0.5 | 4.5 | 1.0 | Creatinine 1.1 mg/dL
Normal Values | | <35 | <30 | <1.2 | >3.8 | <1.2

#### Comment

This man with bacterial endocarditis developed skin rash that was probably misinterpreted as being due to nafcillin and was restarted on vancomycin, the more likely culprit. Within 3 weeks he had a disseminated rash, fever, marked eosinophilia, worsening renal insufficiency and marked elevations in serum aminotransferase levels at which point vancomycin was discontinued. He became jaundiced and was started on prednisone which improved the symptoms of hypersensitivity. The renal and hepatic abnormalities improved slowly but were back in the normal range within the next few months. While he was also taking hydralazine, the time to onset and clinical features were not typical of hydralazine induced liver injury. Most instances of DRESS associated with vancomycin arise within 1 to 6 weeks of starting the medication and are associated with mild or minimal hepatic abnormalities and more prominent renal dysfunction. In this instance, the prolonged therapy probably led to a more serious renal and hepatic involvement. While the hepatic abnormalities were associated with jaundice, the degree of hyperbilirubinemia was mild. Despite that, the INR rose to a level above 1.5 indicating that severe liver injury may have been present. Testing done on a stored serum sample later demonstrated homozygosity for HLA-A*32:01 an allele closely linked to vancomycin-induced DRESS syndrome; this was Case #1 in the publication by Asif et al [2024].

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vancomycin – Generic, Vancocin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=vancomycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Vancomycin | 1404-90-6 | C66-H75-C12-N9-O24
Vancomycin Hydrochloride | 1404-93-9 | C66-H75-C12-N9-O24.Cl-H

## CITED REFERENCES

1 Asif BA, Koh C, Phillips EJ, Gu J, Li YJ, Barnhart H, Chalasani N, et al; Drug Induced Liver Injury Network (DILIN). Vancomycin-induced liver injury, DRESS, and HLA-A*32:01. J Allergy Clin Immunol Pract. 2024;12:168-174.e2. 37739311. [Cases #3 and #1]

## ANNOTATED BIBLIOGRAPHY

References updated: 5 August 2025

Abbreviations: DRESS, drug reaction with eosinophilia and systemic symptoms; HLA, human leukocyte antigen; SJS, Stevens-Johnson syndrome; TEN, toxic epidermal necrolysis; iv, intravenous.

Zimmerman HJ. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 592. (Expert review of liver injury published in 1999; does not mention vancomycin).
Moseley RH. Vancomycin. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 469. (Expert review of antibiotic induced liver injury mentions that a single case report of vancomycin causing ALT elevations has been published).
MacDougall C. Glycopeptides. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1059-61. (Textbook of pharmacology and therapeutics).
Rothenberg HJ. Anaphylactoid reaction to vancomycin. J Am Med Assoc 1959; 171: 1101-2. (17 year old girl with acute bacterial endocarditis developed sudden onset of urticaria, rash, pruritis, chest pain, dyspnea and swelling of face, 10 minutes after receiving an initial dose of intravenous vancomycin [1 gm over 25 minutes], resolving rapidly with epinephrine and Benadryl, described as an “anaphylactoid” reaction). 14439446
Geraci JE, Nichols DR, Wellman WE. Vancomycin in serious staphylococcal infections. Arch Intern Med 1962; 109: 507-15. (Among 85 patients treated with vancomycin, none developed hepatic abnormalities and no instance of anaphylaxis was observed although cases have been described by others). 13897823
Farber BF, Moellering RC Jr. Retrospective study of the toxicity of preparations of vancomycin from 1974 to 1981. Antimicrob Agents Chemother 1983; 23: 138-41. (Analysis of 100 courses of iv vancomycin in 98 patients; fever and rash occurred in 3%, phlebitis 13%, neutropenia 2%, nephrotoxicity 5%, ototoxicity 0%, creatinine rise 35%; no mention of hepatotoxicity or ALT elevations). 6219616
Thompson CM Jr, Long SS, Gilligan PH, Prebis JW. Absorption of oral vancomycin - possible associated toxicity. Int J Pediatr Nephrol 1983; 4: 1-4. (Low levels of vancomycin were detected in serum of an anephric child given drug orally for Clostridium difficile pseudomembranous colitis). 6853034
Sorrell TC, Collignon PJ. A prospective study of adverse reactions associated with vancomycin therapy. J Antimicrob Chemother 1985; 16: 235-41. (Prospective analysis of 54 courses of iv vancomycin given for 4-49 days; rash occurred in 6%, phlebitis 37%, neutropenia 0%, nephrotoxicity 8%, ototoxicity 0%, creatinine rise 50%; slight bilirubin rise in 1 patient; no mention of ALT elevations). 3934126
Garrelts JC, Peterie JD. Vancomycin and the "red man's syndrome". N Engl J Med 1985; 312: 245. (55 year old woman developed flushing, erythematous rash and pruritis 30 minutes into an initial infusion of vancomycin, resolving within 3 hours of stopping, and not recurring with subsequent vancomycin infusions given at a slower rate; first use of the term “red man syndrome”; the authors considered it to be an anaphylactoid reaction). 3155563
Matzke GR, Zhanel GG, Guay DR. Clinical pharmacokinetics of vancomycin. Clin Pharmacokinet 1986; 11: 257-82. (Extensive review of clinical pharmacology of vancomycin; major adverse events are renal toxicity and ototoxicity, skin rash, thrombophlebitis and fever; no mention of liver-related toxicity). 3530582
Healy DP, Polk RE, Garson ML, Rock DT, Comstock TJ. Comparison of steady-state pharmacokinetics of two dosage regimens of vancomycin in normal volunteers. Antimicrob Agents Chemother 1987; 31: 393-7. (Among 11 healthy volunteers given 500 mg of intravenous vancomycin every 6 hours for 5 doses followed one week later by 1000 mg every 12 hours for 3 doses, the flushing syndrome occurred in 9 [89%] taking 1000 mg but in none taking 500 mg). 3579256
Renz CL, Thurn JD, Finn HA, Lynch JP, Moss J. Oral antihistamines reduce the side effects from rapid vancomycin infusion. Anesth Analg 1998; 87: 681-5. (Among 30 patients undergoing joint replacement surgery and receiving prophylactic infusions of vancomycin, rates of acute flushing syndrome were less in those receiving diphenhydramine and cimetidine [11 of 20: 55%] versus placebo [10 of 10: 100%]). 9728853
Healy DP, Sahai JV, Fuller SH, Polk RE. Vancomycin-induced histamine release and "red man syndrome": comparison of 1- and 2-hour infusions. Antimicrob Agents Chemother 1990; 34: 550-4. (Among 10 healthy male volunteers given infusions of 1000 mg of vancomycin over 1 or 2 hours, the flushing syndrome was more frequent with the 1 hour infusion [80% vs 30%] and more severe with higher levels of plasma histamine and higher peak, but similar total concentration of vancomycin). 1693055
Levy M, Koren G, Dupuis L, Read SE. Vancomycin-induced red man syndrome. Pediatrics 1990; 86: 572-80. (Among 650 children who received intravenous vancomycin between 1986 and 1988 at Toronto Children’s Hospital, 11 were reported as having an acute flushing syndrome, ages from premature newborn to 8 years, arising with initial infusion, resolving within 5 minutes to 7 hours). 2216623
Stier GR, McGory RW, Spotnitz WD, Schwenzer KJ. Hemodynamic effects of rapid vancomycin infusion in critically ill patients. Anesth Analg 1990; 71: 394-9. (Among 16 critically ill patients after open heart surgery receiving vancomycin by rapid infusion [1000 mg over 5 minutes], plasma histamine levels were stable and unchanged in all except one patient who developed flushing and pruritus but without hemodynamic changes). 1698040
Killian AD, Sahai JV, Memish ZA. Red man syndrome after oral vancomycin. Ann Intern Med 1991; 115: 410-1. (67 year old woman with pseudomembranous colitis developed severe pruritus and flushing 50 minutes after an initial dose of oral vancomycin [given by nasogastric tube], which did not recur with intravenous administration but did with further oral doses, ameliorated by diphenhydramine and decreasing in severity with each subsequent dose). 1830733
Wallace MR, Mascola JR, Oldfield EC 3rd. Red man syndrome: incidence, etiology, and prophylaxis. J Infect Dis 1991; 164: 1180-5. (Among 33 patients monitored during the first two doses of vancomycin with or without diphenhydramine pretreatment, acute flushing syndrome arose in none of the pretreated subjects but in 8 of 17 placebo recipients, reactions recurring in 3 of 8 first dose reactors with the second dose; plasma histamine levels were elevated in patients developing the flushing syndrome). 1955716
Wilhelm MP. Vancomycin. Mayo Clin Proc 1991; 66: 1165-70. (Extensive review of vancomycin pharmacology, clinical efficacy and adverse events; no mention of hepatotoxicity). 1943250
O'Sullivan TL, Ruffing MJ, Lamp KC, Warbasse LH, Rybak MJ. Prospective evaluation of red man syndrome in patients receiving vancomycin. J Infect Dis 1993; 168: 773-6. (Among 29 patients receiving intravenous vancomycin followed prospectively, only 1 developed the acute flushing syndrome [3%] and plasma histamine levels increased minimally and did not predict flushing). 8354921
Hauben M, Adler C. Acute hepatitis, interstitial nephritis, and eosinophilia. Ann Intern Med 1995; 122: 555-6. (35 year old woman with HIV infection developed acute rise in ALT [from 47 to 2374 U/L] and creatinine [from 0.8 to 7.6 mg/dL] and eosinophilia with no mention of jaundice, within 4 days of starting vancomycin and aztreonam; values improved after stopping, but were still abnormal 7 days later; patient also received a day of erythromycin). 7872595
Alexander II, Greenberger PA. Vancomycin-induced Stevens-Johnson syndrome. Allergy Asthma Proc 1996; 17: 75-8. (36 year old man developed Stevens-Johnson syndrome after 17 days of iv vancomycin, requiring switch to piperacillin and gentamicin with accompanying mild liver injury thereafter [AST 198 U/L, Alk P 232 U/L but no jaundice]; Stevens-Johnson syndrome responded to corticosteroids). 8934797
Martí R, Rosell M, Pou L, García L, Pascual C. Influence of biochemical parameters of liver function on vancomycin pharmacokinetics. Pharmacol Toxicol 1996; 79: 55-9. (Retrospective analysis of 76 patients treated with vancomycin revealed no liver abnormalities). 8878246
Elting LS, Rubenstein EB, Kurtin D, Rolston KVI, Fangtang J, Martin CG, Raad II, et al. Mississippi mud in the 1990s: risks and outcomes of vancomycin-associated toxicity in general oncology practice. Cancer 1998; 83: 2597-607. (765 cancer patients were treated with vancomycin; significant nephrotoxicity, but no hepatotoxicity was noted). 9874468
Renz CL, Thurn JD, Finn HA, Lynch JP, Moss J. Antihistamine prophylaxis permits rapid vancomycin infusion. Crit Care Med 1999; 27: 1732-7. (Among 40 preoperative patients given 1000 mg of vancomycin over 10 minutes with or without premedication with diphenhydramine or cimetidine or placebo, rates of hypotension [11% vs 63%] and rash [63% vs 100%] were less with the antihistamine [anti-H1 or H2] prophylaxis). 10507591
Hassaballa H, Mallick N, Orlowski J. Vancomycin anaphylaxis in a patient with vancomycin-induced red man syndrome. Am J Ther 2000; 7: 319-20. (45 year old woman with systemic lupus and end-stage liver disease developed flushing, tongue swelling emesis, hypotension, and rigors, shortly after initiation of an infusion of vancomycin, progressing to coma and respiratory arrest, but responding to ventilation and supportive measures including corticosteroids and antihistamines). 11317179
Zuliani E, Zwahlen H, Gilliet F, Marone C. Vancomycin-induced hypersensitivity reaction with acute renal failure: resolution following cyclosporine treatment. Clin Nephrol 2005; 64: 155-8. (45 year old woman developed fever 34 days after starting vancomycin followed by rash and renal failure [bilirubin 2.4 mg/dL, ALT 462 U/L, Alk P 257 U/L], treated with prednisone with two relapses during recovery). 16114793
Yazganoglu KD, Ozkaya E, Ergin-Ozcan P, Cakar N. Vancomycin-induced drug hypersensitivity syndrome. J Eur Acad Dermatol Venereol 2005; 19: 648-50. (56 year old woman developed fever, rash, facial edema and eosinophilia [1396/µL] 20 days after starting vancomycin [bilirubin and Alk P not given, ALT 229 U/L], resolving after 2 months on corticosteroid therapy). 16164735
Cadle RM, Mansouri MD, Darouiche RO. Vancomycin-induced elevation of liver enzyme levels. Ann Pharmacother 2006; 40: 1186-9. (57 year old man with Clostridium difficile colitis and persistent diarrhea was treated with oral vancomycin on 5 occasions, developing progressively increasing elevations in ALT [~100-400 U/L] without symptoms or jaundice with each treatment; ALT returned to baseline after each course and vancomycin could not be detected in serum). 16720708
Kwon HS, Chang YS, Jeong YY, Lee SM, Song WJ, Kim HB, Kim YK, et al. A case of hypersensitivity syndrome to both vancomycin and teicoplanin. J Korean Med Sci 2006; 21: 1108-10. (50 year old man with cirrhosis developed fever, rash and eosinophilia [1605/µL] 18 days after starting iv vancomycin [liver test results not provided], resolving on stopping vancomycin, but recurring on intravenous teicoplanin [an antibiotic similar to vancomycin]). 17179696
Tamagawa-Mineoka R, Katoh N, Nara T, Nishimura Y, Yamamoto S, Kishimoto S. DRESS syndrome caused by teicoplanin and vancomycin, associated with reactivation of human herpesvirus-6. Int J Dermatol 2007; 46: 654-5. (52 year old woman developed fever, lymphadenopathy, rash, facial edema and eosinophilia [7%] a few days after starting iv vancomycin [bilirubin not provided, ALT 547 U/L, Alk P 2209 U/L], resolving once vancomycin was stopped and corticosteroids added; positive lymphocyte stimulation test to vancomycin and teicoplanin). 17550572
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to vancomycin). 18955056
Vauthey L, Uçkay I, Abrassart S, Bernard L, Assal M, Ferry T, Djordjevic M, et al. Vancomycin-induced DRESS syndrome in a female patient. Pharmacology 2008; 82: 138-41. (60 year old woman developed fever, rash and facial edema 18 days after starting iv vancomycin [liver tests normal except for GGT of 224 U/L], resolving with corticosteroid therapy). 18607115
Bailey P, Gray H. An elderly woman with 'Red Man Syndrome' in association with oral vancomycin therapy: a case report. Cases J 2008; 1: 111. (82 year old woman with C. difficile diarrhea developed disseminated pruritic rash and headaches 4 days after starting oral vancomycin, responding rapidly to discontinuation and antihistamines; no mention of liver involvement). 18710566
Mennicke M, Zawodniak A, Keller M, Wilkens L, Yawalkar N, Stickel F, Keogh A, et al. Fulminant liver failure after vancomycin in a sulfasalazine-induced DRESS syndrome: fatal recurrence after liver transplantation. Am J Transplant 2009; 9: 2197-202. (60 year old man developed fever, rash and eosinophilia 6 weeks after starting sulfasalazine [bilirubin 2.7 mg/dL, ALT 650 U/L, Alk P 181 U/L]; started on iv vancomycin and ALT rose to 6,745 U/L two days later; emergency liver transplantation was done, after which he developed rash, fever and liver injury again while on piperacillin/tazobactam and caspofungin, dying suddenly of hemorrhage). 19706026
Vinson AE, Dufort EM, Willis MD, Eberson CP, Harwell JI. Drug rash, eosinophilia, and systemic symptoms syndrome: Two pediatric cases demonstrating the range of severity in presentation--A case of vancomycin-induced drug hypersensitivity mimicking toxic shock syndrome and a milder case induced by minocycline. Pediatr Crit Care Med 2010; 11: e38-43. (14 year old boy developed fever and rash 3 weeks after starting iv vancomycin and worsened with continuation [ALT 92 rising to 436 U/L, bilirubin and Alk P not given, eosinophils 16%], responding to stopping drug and corticosteroids). 20407399
Chen Y, Yang XY, Zeckel M, Killian C, Hornbuckle K, Regev A, Voss S. Risk of hepatic events in patients treated with vancomycin in clinical studies: a systematic review and meta-analysis. Drug Saf 2011; 34: 73-82. (Systematic review of 20 controlled trials of iv vancomycin in 7419 patients, found rates of liver enzyme elevations ["hepatic events"] to be 1.8-1.9 times higher with vancomycin than with comparator arms; with vancomycin monotherapy rates were only 0.4% vs 0.3%, while with combination therapy rates were 6.8% vs 3.9%; no reports of clinically apparent liver disease with jaundice). 21142272
Schnetzke U, Bossert T, Scholl S, Freesmeyer M, Hochhaus A, La Rosée P. Drug-induced lymphadenopathy with eosinophilia and renal failure mimicking lymphoma disease: dramatic onset of DRESS syndrome associated with antibiotic treatment. Ann Hematol 2011; 90: 1353-5. (30 year old man developed fever, lymphadenopathy, atypical lymphocytosis, eosinophilia [25%] and acute renal failure while receiving several antibiotics including vancomycin [liver test results not given], resolving with corticosteroid therapy after stopping antibiotics). 21298267
O'Meara P, Borici-Mazi R, Morton AR, Ellis AK. DRESS with delayed onset acute interstitial nephritis and profound refractory eosinophilia secondary to vancomycin. Allergy Asthma Clin Immunol 2011; 7: 16. (66 year old man developed rash 4 weeks after starting iv vancomycin therapy followed by fever [40 ^o^C] and facial edema [bilirubin 0.8 mg/dL, ALT 144 U/L, GGT 354 U/L, eosinophils 3620/µL], with subsequent respiratory and renal failure, followed by a slow, but ultimately full recovery on corticosteroid therapy). 21968185
Fleming P, Marik PE. The DRESS syndrome: the great clinical mimicker. Pharmacotherapy 2011; 31: 332. (44 year old woman with tracheostomy, hemorrhagic stroke and sepsis developed fever, rash and eosinophilia [25%] several days after starting iv vancomycin [bilirubin 0.2 rising to 12.8 mg/dL, ALT 127 U/L, Alk P not provided], responding to corticosteroid therapy). 21361742
Tran NP, Katcher J, Rohman E, Hall MF, Michael CF, Miyairi I, Lew DB. Vancomycin hypersensitivity diagnosed by lymphocyte blast transformation. Case Rep Pediatr 2011; 2011: 562620. (15 year old male developed rash, fever and renal disease 8-10 days after starting vancomycin [eosinophils 980/µL, liver tests not provided], with positive lymphocyte stimulation test to vancomycin and resolution on switching to other antibiotics). 22606516
Blumenthal KG, Patil SU, Long AA. The importance of vancomycin in drug rash with eosinophilia and systemic symptoms (DRESS) syndrome. Allergy Asthma Proc 2012; 33: 165-71. (Among 6 cases of DRESS syndrome seen at a single referral hospital over an 18 month period, 5 arose 12 days to 4 weeks after starting iv vancomycin therapy with fever, rash and eosinophilia [bilirubin 1.8 mg/dL in one patient, ALT 75-347 U/L, Alk P 181-378 U/L], 4 had history of allergies, 3 were treated with corticosteroids, 2 had at least one relapse, and all ultimately resolved). 22525393
Müller PA, Amann K, Bröcker EB, Trautmann A. [Maculo-papular exanthem with acute renal failure. Drug-induced hypersensitivity syndrome]. Hautarzt 2012; 63: 223-5. German. (44 year old man developed fever, rash, eosinophilia [3601/µL] and renal injury 4 weeks after starting iv vancomycin [liver tests not provided], resolving with corticosteroid therapy). 21971769
Díaz-Mancebo R, Costero-Fernández O, Vega-Cabrera C, Olea-Tejero T, Yébenes L, Picazo ML, Selgas-Gutiérrez R. Dress syndrome and acute tubulointerstitial nephritis after treatment with vancomycin and beta-lactams. Case report and literature review. Nefrologia 2012; 32: 685-7. (74 year old woman developed rash, fever, eosinophilia and renal failure several weeks after starting vancomycin [ALT raised, values not given], with slow resolution on corticosteroid therapy). 23013963
Kitcharoensakkul M, Ree N, Bloomberg GR, Dehner LP, Heidingsfelder JA, White AJ, Cooper MA. Vancomycin-induced DRESS with evidence of T-cell activation in a 22-month-old patient. Ann Allergy Asthma Immunol 2012; 109: 280-1. (22 year old woman developed fever, rash and eosinophilia 17 days after starting iv vancomycin [hepatomegaly noted but no liver tests provided], improving on corticosteroid therapy, but dying suddenly 18 days after hospital discharge). 23010236
Dauby N, Fink W, Seyler L, Luce S, Nouwynck C, Tas S, Jacobs F. Probable hypersensitivity reaction to vancomycin associating rash, fever and neutropenia. Acta Clin Belg 2012; 67: 226-8. (54 year old woman with cancer developed fever after 7 days of vancomycin therapy followed by rash and, with restarting vancomycin, neutropenia and serum ALT elevations ["up to 3 times normal"], resolving rapidly upon stopping vancomycin). 22897075
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to vancomycin). 23419359
Song SM, Cho MS, Oh SH, Kim KM, Park YS, Kim DY, Lee SG. Liver transplantation in a child with acute liver failure resulting from drug rash with eosinophilia and systemic symptoms syndrome. Korean J Pediatr 2013; 56: 224-6. (14 year old girl developed fever, rash and abnormal liver tests 5 weeks after starting vancomycin for a MRSA wound infection [bilirubin 3.3 rising to 15.5 mg/dL, ALT 263 to 1077 U/L, Alk P 440 U/L, eosinophils 3150/μL], worsening despite methylprednisone and undergoing liver transplant within 9 days of onset). 23741237
Della-Torre E, Yacoub MR, Pignatti P, Della-Torre F, Sabbadini MG, Colombo G, Tresoldi M. Optimal management of DRESS syndrome in course of infectious endocarditis. Ann Allergy Asthma Immunol 2013; 110: 303-5. (75 year old man developed fever and rash 27 days after starting vancomycin, gentamicin and rifampin for endocarditis [bilirubin not given, ALT 264 U/L, Alk P 247 U/L, eosinophils 6%], with resolution within 8 weeks on methylprednisone and IVIG). 23535099
Bhardwaj N, Ishmael FT. Cytokine gene expression profiling to help identify a safe antibiotic in a patient with drug rash with eosinophilia and systemic symptoms. J Allergy Clin Immunol Pract 2013; 1: 531-3. (53 year old man developed rash, fever, eosinophilia [36%] and creatinine elevation [liver tests not done] during week 3 of vancomycin and cefepime therapy, recovering with stopping both antibiotics but subsequent rash after single doses of each drug; follow up in vitro assays for cytokine expression after exposure to both drugs were positive). 24565631
Young S, Ojaimi S, Dunckley H, Douglas MW, Kok J, Fulcher DA, Lin MW, et al. Vancomycin-associated drug reaction with eosinophilia and systemic symptoms syndrome. Intern Med J 2014; 44: 694-6. (Two men and one woman, ages 24 to 59 years developed rash, fever, eosinophilia, atypical lymphocytosis and ALT elevations [113 to 337 U/L, bilirubin not provided] 2-3 weeks after starting vancomycin resolving with corticosteroid therapy; HLA testing was positive for A*32 in two of the three). 25041771
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attribute to vancomycin). 24552865
Sultan SJ, Sameem F, Ashraf M. Drug reaction with eosinophilia and systemic symptoms: manifestations, treatment, and outcome in 17 patients. Int J Dermatol 2015; 54: 537-42. (Among 17 patients with DRESS syndrome seen at a referral center in India over a 4 year period, most cases [65%] were due to aromatic anticonvulsants, 2 to allopurinol and 1 each for vancomycin, leflunomide, dapsone and nitrofurantoin, with ALT elevations above 100 U/L in all 17, hyperbilirubinemia in 65% and liver failure in one). 24738653
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 363 [36%] were attributed to antibiotics, three of which were due to vancomycin all of them occurring after 2008). 25754159
Korman TM, Turnidge JD, Grayson ML. Vancomycin vintage: my favourite DRESS. Intern Med J 2015; 45: 233-4. (Letter in response to report by Young [2014] mentioning that vancomycin associated DRESS syndrome was first reported in the 1960s but was attributed to contaminants, but similar cases have been described even after improved methods of purification of vancomycin, skin rash occurring in at least 5% of patients with accompanying eosinophilia in most). 25650542
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol 2015; 136: 1288-94.e1. (Among 824 patients who underwent outpatient parenteral antibiotic therapy for at least 2 weeks, 210 [25%] developed eosinophilia [500 to 8260 cells/uL], the highest rate being among recipients of vancomycin [30%: 95 of 314], rates of DRESS syndrome and liver involvement not provided). 25981739
Güner MD, Tuncbilek S, Akan B, Caliskan-Kartal A. Two cases with HSS/DRESS syndrome developing after prosthetic joint surgery: does vancomycin-laden bone cement play a role in this syndrome? BMJ Case Rep 2015; 2015:bcr2014207028. (Two patients who underwent orthopedic prosthesis replacement using vancomycin-laden bone cement followed by intravenous vancomycin developed fever, rash, eosinophilia and creatine elevations [one had ALT elevations as well] 2 and 4 weeks following initiation of parenteral vancomycin and both responded to high dose corticosteroid therapy). 26021379
Adams B, Roboubi B, Henshaw R. Acute onset of vancomycin anaphylaxis with disseminated intravascular coagulation in an orthopedic patient despite prior repeated exposure. Am J Orthop (Belle Mead NJ) 2015; 44: E523-5. (55 year old woman with a prosthetic infection and multiple previous exposures to vancomycin developed hypotension, without rash, fever or eosinophilia, during an infusion of vancomycin during surgery, responding to stopping the infusion and resuscitation thought to be due to anaphylaxis). 26665256
McNeil BD, Pundir P, Meeker S, Han L, Undem BJ, Kulka M, Dong X. Identification of a mast-cell-specific receptor crucial for pseudo-allergic drug reactions. Nature 2015; 519: 237-41. (In vitro and in vivo data demonstrate that mast cell degranulation can be induced by a range of cationic peptidergic drugs via direct engagement of G-protein linked receptors on mast cells [MRGPR] which causes release of granules with histamine, tumor necrosis factor, prostaglandin D, interleukins and other active amines). 25517090
Kumar T, Teo I, McCormick BB. Systemic toxicity of intraperitoneal vancomycin. Case Rep Nephrol 2016; 2016: PMID: 3968690. (45 year old man with end-stage renal disease on peritoneal dialysis developed rash, fever and hypotension 3 weeks after starting peritoneal doses of vancomycin with normal ALT, Alk P and bilirubin levels responding to corticosteroids; authors mention 3 other case reports of hypersensitivity to Intraperitoneal vancomycin but no mention of hepatic involvement).
Kim KM, Sung K, Yang HK, Kim SH, Kim HY, Ban GH, Park SE, et al. Acute tubular necrosis as a part of vancomycin induced drug rash with eosinophilia and systemic symptoms syndrome with coincident postinfectious glomerulonephritis. Korean J Pediatr 2016; 59: 145-8. (11 year old boy developed fever, rash and edema after a 10 day course of vancomycin and ceftriaxone with eosinophilia [24%] and proteinuria but normal serum ALT and AST, eventually improving with corticosteroid therapy but with residual nephrotic syndrome). 27186222
Sousa JM, Nascimento H, Belfort R Junior. DRESS syndrome in ophthalmic patients. Arq Bras Oftalmol 2016; 79: 192-4. (Two patients with DRESS syndrome after antibiotic therapy of endophthalmitis [intravenous cephalothin and intravitreous vancomycin] and vitritis [parenteral sulfadiazine/pyrimethamine], both resolving with high dose corticosteroids and stopping the implicate antibiotics). 27463633
Webb PS, Al-Mohammad A. Enigma: infection or allergy? vancomycin-induced DRESS syndrome with dialysis-dependent renal failure and cardiac arrest. BMJ Case Rep 2016; 2016:bcr2016215911. (73 year old man with culture negative endocarditis developed fever, rash and eosinophilia after 23 days of antibiotic therapy including intermittent use of vancomycin, ultimately resolving with stopping the implicated agents and starting corticosteroid therapy; acute renal dysfunction requiring temporary dialysis but no mention of liver test abnormalities). 27571915
Miyazu D, Kodama N, Yamashita D, Tanaka H, Inoue S, Imakyure O, Hirakawa M, et al. DRESS syndrome caused by cross-reactivity between vancomycin and subsequent teicoplanin administration: a case report. Am J Case Rep 2016; 17: 625-31. (79 year old man with a complicated wound infection after traumatic injury developed fever and erythema after 18 days of vancomycin therapy with subsequent eosinophilia and pneumonitis, improving when switched to teicoplanin and given corticosteroids, but relapsed 12 days later, improving when antibiotic was switched to linezolid suggesting cross sensitivity to DRESS syndrome of the two somewhat similar glycopeptide antibiotics). 27572807
Evans T, Patel S. Two consecutive preoperative cardiac arrests involving vancomycin in a patient presenting for hip disarticulation: a case report. A A Case Rep 2017; 9: 262-4. (59 year old woman receiving vancomycin in preparation of hip surgery developed sudden hypotension and cardiac arrest which successful resuscitation and had the identical response to an infusion of vancomycin given 4 weeks later, the initial episode having been attributed to another agent [midazolam]; no mention of rash, fever or pruritus). 28622151
Mattoussi N, Ben Mansour A, Essadam L, Guedri R, Fitouri Z, Ben Becher S. Drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome in children: a case report. J Investig Allergol Clin Immunol 2017; 27: 144-6. (14 year old boy with sickle cell-thalassemia and acute septicemia developed fever and lymphadenopathy followed by rash, facial edema and eosinophilia after 2-3 weeks of intravenous vancomycin and cefotaxime [ALT 313 U/L, bilirubin 1.2 mg/dL], responding to stopping antibiotics and use of antihistamines; follow up patch tests were positive for vancomycin only). 28398207
Maxfield L, Schlick T, Macri A, Thatcher J. Vancomycin-associated drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome: masquerading under the guise of sepsis. BMJ Case Rep 2017; 2017:bcr2017221898. (52 year old man developed fever and confusion thought to be due to sepsis, but not responding to antibiotics and arising 3 weeks after receiving vancomycin for osteomyelitis, ultimately manifested by rash, lymphadenopathy, eosinophilia and liver and renal test abnormalities [ALT 136 U/L, Alk P 240 U/L, creatinine 1.3 rising to 3.8 mg/dL], responding to high dose methylprednisolone). 29054953
Lam BD, Miller MM, Sutton AV, Peng D, Crew AB. Vancomycin and DRESS: A retrospective chart review of 32 cases in Los Angeles, California. J Am Acad Dermatol 2017; 77: 973-5. (Among 32 patients diagnosed with DRESS syndrome at two California hospitals over a 3 year period, vancomycin was the most frequently implicated agent [n=12: 38%]). 29029908
Wilcox O, Hassanein M, Armstrong J, Kassis N. Case report: atypical presentation of vancomycin induced DRESS syndrome: a case report and review of the literature. BMC Pulm Med 2017; 17: 217. (39 year old man with osteomyelitis developed fever and shortness of breath after 3 weeks of intravenous vancomycin therapy followed by severe respiratory distress syndrome, acute kidney injury, rash, fever and eosinophilia, responding rapidly to stopping vancomycin and use of high doses of corticosteroids). 29282040
Azimi E, Reddy VB, Lerner EA. Brief communication: MRGPRX2, atopic dermatitis and red man syndrome. Itch (Phila) 2017; 2: e5. (Mast cells can be degranulated by IgE independent pathways via engagement of specific G-protein linked receptors which are activated by vancomycin causing degranulation, an action that can be blocked by inhibition of MRGPRX2). 28367504
Hashizume H, Kageyama R, Kaneko Y. Short course of cyclosporin A as a treatment option for drug-induced hypersensitivity syndrome: Case reports and review of the published work. J Dermatol 2018; 45: e169-e170. (Two adults with hypersensitivity reactions marked by rash, fever and eosinophilia attributed to medications [Case 1: lamotrigine, Case 2 vancomycin] treated successfully with a 7 day course of oral cyclosporin [3 mg/kg/day] and review of the literature of 4 similarly treated cases with successful outcomes]; no mention of hepatic involvement). 29315746
Nagahama Y, VanBeek MJ, Greenlee JDW. Red man syndrome caused by vancomycin powder. J Clin Neurosci 2018; 50: 149-50. (73 year old man developed intense erythema around site of vancomycin powder application during placement of a medical device, 2 days after surgery, resolving with symptomatic therapy only; no mention of liver test abnormalities). 29398192
Lin YC, Sheu JN, Chung WH, Pan RY, Hung CJ, Cheng JJ, Hsiao YP. Vancomycin-induced Stevens-Johnson syndrome in a boy under 2 years old: an early diagnosis by granulysin rapid test. Front Pediatr 2018; 6: 26. (19 month old boy developed rash after 13 days of vancomycin therapy for empyema which worsened and became generalized with blistering and oral ulcers by 30 days, with positive results using a granulysin assay; no mention of liver involvement). 29594082
Littlehales E, Murray O, Dunsmuir R. Vancomycin-induced DRESS syndrome: an important concern in orthopedic surgery. Case Rep Orthop 2018; 2018: PMID: 1439073. (62 year old man with postoperative spinal infection developed a maculopapular rash 7 weeks after starting intravenous vancomycin progressing to extensive, pruritic and painful rash and exfoliation, with fever, lymphadenopathy and eosinophilia but without hepatic or renal abnormalities treated with topical steroids and antihistamines only).
Castellazzi ML, Esposito S, Claut LE, Daccò V, Colombo C. Drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome in two young children: the importance of an early diagnosis. Ital J Pediatr 2018; 44: 93. (Two cases of DRESS syndrome in children, ages 5 and 4 years with onset of rash 30 and 14 days after starting intravenous vancomycin with fever, lymphadenopathy, eosinophilia and ALT elevations [peak 132 and 311 U/L], both resolving after stopping drug, one requiring a 3 day pulse of corticosteroids and one not). 30111350
Chamorro-Pareja N, Patel A, Youngberg G, Gonzalez-Estrada A. Case of drug reaction with eosinophilia and systemic symptoms secondary to vancomycin. BMJ Case Rep 2018; 2018:bcr2018227378. (38 year old man developed rash, fever, facial edema, lymphadenopathy, eosinophilia and atypical lymphocytosis 3 weeks after starting intravenous vancomycin for osteomyelitis, resolving with corticosteroid therapy; no mention of ALT elevations). 30301733
Sun Y, Huskey RL, Tang L, Inaba H, Gaur AH, Ribeiro R, Rubnitz JE, Wolf J. Adverse effects of intravenous vancomycin-based prophylaxis during therapy for pediatric acute myeloid leukemia. Antimicrob Agents Chemother 2018; 62:e01838-17. (Among 116 children with acute myelogenous leukemia treated with 392 courses of chemotherapy, rates of any ALT elevations were similar in those given vancomycin prophylaxis [47%] and those given no prophylaxis [57%] while rates of C. difficile infection were less). 29229640
Khanal S, Ghimire P, Dhamoon AS. Liver injury during treatment with rifampicin, vancomycin, and acetaminophen. Am J Ther 2018; 25: e735-e737. (40 year old man with osteomyelitis developed abnormal liver tests while being treated with acetaminophen, vancomycin and rifampin [ALT rising from 8 to 224 to 735 U/L, bilirubin peak 2.1 mg/dL, no mention of fever, rash or eosinophilia], resolving with stopping all three medications). 29557806
Wolfson AR, Zhou L, Li Y, Phadke NA, Chow OA, Blumenthal KG. Drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome Identified in the Electronic Health Record Allergy Module. J Allergy Clin Immunol Pract 2019; 7: 633-40. (Search of electronic medical records from more than 3 million subjects identified 69 cases of DRESS syndrome [~2 per 100,000 population], the most common causes of which were vancomycin [n=29], penicillin [13], phenytoin [10], cephalosporins [7] and lamotrigine [6]). 30176295
Madigan LM, Fox LP. Vancomycin-associated drug-induced hypersensitivity syndrome. J Am Acad Dermatol 2019; 81: 123-8. (Among 19 cases of DRESS syndrome seen over an 8 year period at a single US referral center, 4 were attributed to vancomycin, 3 of whom had renal involvement which is typical of cases caused by vancomycin). 30738120
Konvinse KC, Trubiano JA, Pavlos R, James I, Shaffer CM, Bejan CA, Schutte RJ, et al. HLA-A*32:01 is strongly associated with vancomycin-induced drug reaction with eosinophilia and systemic symptoms. J Allergy Clin Immunol 2019; 144: 183-92. (Among patients with a history of vancomycin induced DRESS syndrome identified between 2004 and 2018, HLA typing demonstrated the A*32:01 allele in 19 of 23 [83%] of DRESS cases compared to none of 46 matched vancomycin-tolerant subjects and to a carrier rate of 6.3% in population controls, vancomycin fitting into the antigen groove of HLA-A*32:01 in molecular docking prediction analyses). 30776417
Pirmohamed M. HLA- and immune-mediated adverse drug reactions: another hit with vancomycin. J Allergy Clin Immunol 2019; 144: 44-5. (Editorial accompanying Konvinse [2019] discussing role that HLA associations can play in prevention, risk management and diagnosis of drug adverse events). 31029771
Maldonado D, Lakhani J. Vancomycin-induced DRESS syndrome treated with systemic steroids in a 16-year-old male. SAGE Open Med Case Rep 2019; 7: 2050313X19841704. (16 year old adolescent boy developed fever, rash, sore throat and eosinophilia after completing a 4 week course of vancomycin for a bone infection, responding rapidly to switching to doxycycline and high dose corticosteroids).
Roy S, Goswamy VP, Barssoum KN, Rai D. Vancomycin-induced drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome masquerading as elusive sepsis. Case Reports Immunol 2019; 2019: PMID: 1625010. (37 year old woman injection drug user was admitted for therapy for septic pulmonary emboli and continued to have fever during vancomycin therapy, then developing rash, rise in ALT levels [1192 U/L], eosinophilia and renal dysfunction [creatinine 1.4 mg/dL], improving once vancomycin was stopped and corticosteroids started).
Sim DW, Yu JE, Jeong J, Jung JW, Kang HR, Kang DY, Ye YM, et al.; Korean Severe Cutaneous Adverse Reactions Consortium. Variation of clinical manifestations according to culprit drugs in DRESS syndrome. Pharmacoepidemiol Drug Saf 2019; 28: 840-8. (Among 123 patients with DRESS syndrome enrolled in a prospective Korean adverse event registry, the most common causes were allopurinol [n=28], carbamazepine [22], antituberculosis drugs [19], vancomycin [18], cephalosporins [15], dapsone [11] and NSAIDs [10]; liver involvement was present in 56-100% [the lowest rate with vancomycin] and renal involvement in 9-79% [the highest rates with allopurinol and vancomycin], and with 6 deaths [5%], 2 due to vancomycin). 31044478
Rwandamuriye FX, Chopra A, Konvinse KC, Choo L, Trubiano JA, Shaffer CM, Watson M, et al. A rapid allele-specific assay for HLA-A*32:01 to identify patients at risk for vancomycin-induced drug reaction with eosinophilia and systemic symptoms. J Mol Diagn 2019; 21: 782-9. (Description of an allele specific PCR method for rapid detection of HLA-A*32:01 that correctly identified all 30 positive DNA samples and was negative on all 428 negative samples that had been typed using formal sequence based methods). 31158526
Gangireddy M, Sarao MS, Shrimanker I, Nookala VK. A fatal case of vancomycin associated drug reaction with eosinophilia and systemic symptoms syndrome in a septuagenarian. Cureus 2019; 11: e5015. (79 year old woman developed abdominal pain, jaundice and rash 6 weeks after starting parenteral vancomycin and cefepime [bilirubin 14.2 rising to 22.2 mg/dL, ALT 674 U/L, Alk P 2742 U/L, creatinine 5.0 mg/dL], with progressive liver failure and death from multiorgan failure despite stopping vancomycin and use of high dose corticosteroids). 31497445
Ercan N, Yeşillik S, Demirel F, Tırık N, Kartal Ö. Haplotype analysis in a 16-year-old boy with vancomycin-induced DRESS syndrome. Pediatr Dermatol 2019; 36: 992-4. (16 year old boy with meningoencephalitis developed rash, fever, lymphadenopathy and periorbital edema 10 days after starting vancomycin with atypical lymphocytosis, ALT 244 U/L, but normal tests of kidney function, responding to a course of corticosteroid therapy with no residual in follow up). 31497897
Arroyo-Mercado F, Khudyakov A, Chawla GS, Cantres-Fonseca O, McFarlane IM. Red man syndrome with oral vancomycin: a case report. Am J Med Case Rep 2019; 7: 16-7. (75 year old woman with C. difficile diarrhea developed flushing, erythema and pruritis involving face, neck and upper torso after the 7th dose of oral vancomycin, responding to discontinuation and antihistamines; no mention of liver involvement).
Swali R, Ghazarian A. The case of the magenta woman (DRESS syndrome). Proc (Bayl Univ Med Cent) 2019; 33: 115-6. (44 year old woman with osteomyelitis developed DRESS syndrome 1 month after starting intravenous vancomycin with disseminated rash, facial edema, eosinophilia and renal insufficiency [creatinine 5.4], responding to corticosteroid therapy; no mention of ALT elevations or hepatic involvement). 32063794
Hewitson LJ. Vancomycin induced DRESS syndrome (drug reaction with eosinophilia and systemic symptoms) in a patient with tricuspid endocarditis. BMJ Case Rep 2019; 12: e229590. (57 year old man with infected cardiac pacemaker developed DRESS syndrome 21 days after starting vancomycin therapy with fever, rash, lymphadenopathy, eosinophilia, ALT elevations [peak 1166 U/L], epigastric pain and severe hypoxia, not improving upon stopping vancomycin but resolving rapidly with initiation of high dose prednisolone therapy). 31527200
Zafar S, Decastro A, Pal S, Pandav J, Kanaparthy N. Vancomycin-induced DRESS syndrome. Ann Allergy Asthma Immunol 2020; 124: 107-8. (Two cases of DRESS syndrome caused by vancomycin: 30 year old man with endocarditis and 63 year old woman with osteomyelitis developed rash, fever, and eosinophilia 4 weeks after starting vancomycin, raised ALT levels being found in one). 31513907
Yuan K, Awan KS, Long J. Vancomycin-induced drug rash with eosinophilia and systemic symptoms (DRESS). BMJ Case Rep 2020; 13: e232302. (52 year old man with osteomyelitis developed fever, rash, and facial edema after 4 weeks of vancomycin and ertapenem therapy with subsequent eosinophilia [2026/µL], atypical lymphocytosis, elevation of serum creatinine but normal liver enzymes, responded quickly to stopping vancomycin and a course of corticosteroids). 32024716
Mukit W, Cooper R, Moudgil H, Ahmad N. DRESS syndrome: an important differential for eosinophilia with systemic organ dysfunction. BMJ Case Rep 2020; 13: e234251. (74 year old woman with pneumonia on antibiotic therapy developed persistent fever, rash, eosinophilia, mild ALT elevations [68 U/L] and renal dysfunction starting 2 weeks after initiation of vancomycin therapy, improving with stopping and without corticosteroid therapy). 32398248
Nakkam N, Gibson A, Mouhtouris E, Konvinse KC, Holmes N, Chua KY, Deshpande P, et al. Cross-reactivity between vancomycin, teicoplanin, and telavancin in patients with HLA-A*32:01-positive vancomycin-induced DRESS sharing an HLA class II haplotype. J Allergy Clin Immunol 2020: S0091-6749(20)30687-4. (Lymphocytes from 15 patients with a history of vancomycin induced DRESS syndrome were incubated with two different doses of vancomycin and related glycopeptide antibiotics and assessed for interferon gamma production using Elispot assays; all 15 samples had a positive response to vancomycin while only 3 reacted to telavancin and 2 to teicoplanin but none to dalbavancin, suggesting low levels of cross reactivity among the agents to inducing DRESS).
Clark D, Alomari AK, Burton K, Rahnama-Moghadam S. A case of vancomycin-induced drug rash with eosinophilia and systemic symptoms (DRESS) syndrome with failure to respond to cyclosporine treatment. Dermatol Online J 2020;26:13030/qt1bx778dt. (“Young” woman with acute bacterial endocarditis being treated with vancomycin for 4 weeks underwent minimally invasive cardiac valve repair and developed facial edema the next day which worsened with high fevers and marked eosinophilia despite stopping vancomycin and starting cyclosporin, resolving rapidly when switched to methylprednisolone).
Martel TJ, Jamil RT, King KC. Red man syndrome. 2020 Apr 27. In: StatPearls [Internet]. Treasure Island (FL): StatPearls Publishing; 2020 Jan–. (Review of red man syndrome, a reaction of flushing, erythema and pruritus generally arising with the first dose of vancomycin, particularly when given rapidly in high doses, probably caused by sudden degranulation of mast cells releasing bioactive amines such as histamine; the reaction may be accompanied by fatigue, back pain and angioedema but is not mediated by IgE and generally is less severe with subsequent infusions and is at least partially ameliorated by pretreatment with antihistamines).
Austin JP, Foster BA, Empey A. Replace red man syndrome with vancomycin flushing reaction. Hosp Pediatr 2020; 10: 623-4. (Appeal to drop the term red man syndrome, as the flushing reaction also occurs in women and in children and “red man” is an unnecessary, racially derogatory term). 32571794
De Luca JF, Holmes NE, Trubiano JA. Adverse reactions to vancomycin and cross-reactivity with other antibiotics. Curr Opin Allergy Clin Immunol 2020; 20: 352-61. (Review of the chemical structures, mechanisms of action and immunologic adverse reactions of vancomycin and related antibiotics, including red man syndrome, IgE mediated anaphylaxis, and T-cell mediated severe cutaneous reactions such as DRESS and SJS; there is no clear evidence for immunologic cross reactivity among the glycol- and lipoglyco-peptides). 32590503
Cox M, Paviour S, Gregory S, Chew R. When fever is more than infection: two cases of vancomycin-induced drug reaction with eosinophilia and systemic symptoms (DRESS). BMJ Case Rep. 2021;14:e238006.. (Two cases of vancomycin induced DRESS syndrome, 71 year old woman and 46 year old man developed fever and rash 19 and 35 days after starting continuous infusions of vancomycin for multi-drug resistant bacterial joint infections with subsequent eosinophilia and both renal and hepatic injury). 33414117
Guo YM, Ge FL, Song HB, Xiong P, Jing J, Niu M, Zhao X, et al. Relative risk analysis of liver-related adverse drug reactions in children based on China's National Spontaneous Reporting System. J Pediatr. 2021;234:85-91.. (Search of the Chinese National Spontaneous Reporting System for adverse liver related events in children from 2012 to 2016 identified 1745 reports implicating 131 drugs, most frequently methotrexate [140], azithromycin [130], rifampin [94], isoniazid [87], meropenem [75], cytarabine [71], pyrazinamide [68], and vancomycin [68]). 33794217
Jafry AH, Nimri J, Akhtar KH, Qureshi S, Bray-Hall S. Amoxicillin-clavulanate induced DRESS syndrome masquerading as red man syndrome. J Family Med Prim Care. 2022;11:3992-3995.. (32 year old man developed rash and fever 10 days after starting intravenous vancomycin for endocarditis with eosinophilia, rise in creatinine, and liver injury [bilirubin 0.6 mg/dL, ALT 63 rising to 514 U/L] attributed to amoxicillin/clavulanate based upon history of rash with its use). 36387629
Wang M, Tang L. Vancomycin-induced elevation of liver enzyme levels in a 3-year-old boy with bacterial meningitis: A pediatric case report. J Am Pharm Assoc (2003). 2023;63(4):1242-1244. PMID: 37028760. (3 year old boy with bacterial meningitis was treated with ceftriaxone and vancomycin for 22 days when abnormal liver tests [ALT 337 U/L, GGT 68 U/L] were found without fever, rash, or jaundice and which improved upon switching from vancomycin to linezolid).
Asif BA, Koh C, Phillips EJ, Gu J, Li YJ, Barnhart H, Chalasani N, et al; Drug Induced Liver Injury Network (DILIN). Vancomycin-induced liver injury, DRESS, and HLA-A*32:01. J Allergy Clin Immunol Pract. 2024;12:168-174.e2.. (Among 1697 cases of drug induced liver injury enrolled in a U.S. prospective study between 2004 and 2020, 9 were attributed to intravenous vancomycin, with median age of 60 years, latency 26 days, 8 with DRESS syndrome, and 7 [78%] with HLA-A*32:01, an allele found in less than 7% of control populations: Cases 1 and 2). 37739311
Lindley B, Bhakta Z, Leclair L, Young DC. The pharmacokinetics and pharmacodynamics of continuous infusion vancomycin in adult people with cystic fibrosis. Pediatr Pulmonol. 2024;59:89-94.. (Among 20 adults with cystic fibrosis treated with continuous infusion vancomycin and monitored for drug pharmacokinetics, none developed infusion reactions or acute renal injury, but two developed evidence of acute liver injury, but no details were given of the timing, symptoms, laboratory test results, or outcomes). 37792309
Wu J, Zhou Y. Case analysis of hepatotoxicity caused by vancomycin. J Med Case Rep. 2024;18:267.. (Among 4562 Chinese adults treated with vancomycin, 17 developed evidence of liver injury including 12 men and 5 women, ages 17 to 84 [mean=45.4] years, latency 2 to 12 days, 10 asymptomatic, 5 with fatigue and 2 jaundice, 13 with fever but none with rash). 38831463
Björnsson RA, Sigurdsson SS, Arnarson DT, Logason E, Björnsson ES. The frequency of drug-induced liver injury due to antibiotics among hospitalised patients. Drug Saf. 2025;48:795-804.. (Among 3931 patients treated with intravenous vancomycin in the National University Hospital of Iceland between 2012 and 2023, 2 developed evidence of liver injury (none were jaundiced) yielding a rate of liver injury of 1 per 1966 persons exposed). 40072769
Rahnama-Moghadam S, Arora N, Vuppalanchi R, Li YJ, Gu J, Barnhart H, Phillips E, et al.; Drug Induced Liver Injury Network. DRESS Syndrome in patients with drug-induced liver injury: characteristics and HLA risk factors. Am J Gastroenterol. 2025 Jun 12. Epub ahead of print.. (Among 2121 patients with drug-induced liver injury enrolled in a U.S. prospective study between 2004 and 2023, 128 had DRESS syndrome, 20 due to SMZ/TMP, 13 lamotrigine, 10 phenytoin, 7 allopurinol, 6 vancomycin,6 sulfasalazine, and 5 carbamazepine, all with rash, 76% with fever, and 55% with eosinophilia; DRESS was associated with HLA alleles A*32:01, B*53:01, and B*58:01, with more severe liver injury, and with African ancestry). 40504263

## OTHER REFERENCE LINKS

1. Recent References on Vancomycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(vancomycin/AE+OR+vancomycin/PD)+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Vancomycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=vancomycin)